# Flurazepam

## OVERVIEW

### Introduction

Flurazepam is an orally available benzodiazepine used for therapy of insomnia. As with most benzodiazepines, flurazepam has not been associated with serum aminotransferase or alkaline phosphatase elevations during therapy, and clinically apparent liver injury from flurazepam has been reported, but is rare.

### Background

Flurazepam (flur az' e pam) is a benzodiazepine used as a sleeping aid in the therapy of insomnia. The sedating and soporific activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA-A receptor. Flurazepam was approved in the United States in 1970 for the short term management of insomnia. For many years flurazepam was one of the most prescribed medications for sleep. Currently, it is less commonly used, having been replaced by benzodiazepines and benzodiazepine analogues with shorter half-life and better tolerance. Flurazepam is available in multiple generic forms and formerly under the brand name of Dalmane in capsules of 15 and 30 mg. The recommended dose for adults is 15 or 30 mg shortly before bedtime. Chronic use is often followed by tolerance and decrease in effectiveness. The most common side effects of flurazepam are dose related and include daytime drowsiness, lethargy, and dizziness. Flurazepam like all oral benzodiazepines has a boxed warning in its product label stressing (1) the risks of severe sedation and potentially fatal respiratory depression when combined with opiates, (2) with prolonged use, the risks of abuse, misuse, and addiction which can lead to overdose and death, and (3) with continue use, the risks of dependence and severe, potentially life-threatening withdrawal symptoms if discontinued suddenly. Benzodiazepines are all categorized as Schedule IV controlled substances, having potential for dependence, tolerance and abuse.

### Hepatotoxicity

Flurazepam, as with other benzodiazepines, is rarely associated with serum ALT or alkaline phosphatase elevations, and clinically apparent liver injury is rare. Only a few case reports of acute liver injury from flurazepam have been published and mostly before 1980. The latency to onset of acute liver injury varied between 2 to 6 months and the pattern of liver enzyme elevations was cholestatic. The injury was usually mild-to-moderate in severity and self-limited in course. Fever and rash were not described nor autoantibody formation. Similar rare cases of self-limited, mild-to-moderate, cholestatic liver injury have been reported with other benzodiazepines including alprazolam, chlordiazepoxide, clonazepam, diazepam, lorazepam, and triazolam.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Flurazepam is metabolized extensively in the liver to its active metabolite that is then excreted in the urine. The liver injury from benzodiazepines is probably due to a rarely produced intermediate metabolite.

### Outcome and Management

The hepatic injury due to benzodiazepines in case reports was followed by prompt and complete recovery upon stopping the medication, without evidence of residual or chronic injury. There have been no case reports of acute liver failure and no instances of chronic liver injury attributed to flurazepam. There is little information about cross reactivity with other benzodiazepines, but some degree of cross sensitivity may occur.

Drug Class: Sedatives and Hypnotics, Benzodiazepines

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to flurazepam.(1)

A 70 year old man developed anorexia, weakness and fatigue 2 months after starting flurazepam for insomnia. Two and a half months later he developed dark urine and jaundice. He had no previous history of liver disease or risk factors for acquiring hepatitis and drank no alcohol. He had coronary artery disease, angina pectoris and type 2 diabetes for which he took chlorthalidone, isosorbide dintitrate, digoxin and tolbutamide chronically. On admission, he was jaundiced, but had no fever or rash. Liver tests, which had been normal before starting flurazepam, were elevated (Table). Ultrasound of the abdomen was unremarkable, HBsAg was negative, and a percutaneous cholangiogram was normal. A liver biopsy showed intrahepatic cholestasis. Flurazepam was stopped and liver tests improved, although pruritus took 4 months to resolve. The other medications were apparently continued.

#### Key Points

Medication: | Flurazepam (30 mg orally nightly as needed)
Pattern: | Mixed→cholestatic (R=2.4→1.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 months until nausea, 4.5 months to jaundice
Recovery: | Complete recovery 4 months after stopping
Other medications: | Isosorbide dinitrate, chlorthalidone, digoxin, tolbutamide

#### Laboratory Values

Time After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 40 | 90 | 0.5
0 | Flurazepam started
4.5 months | | 225 | 207 | 7.0
5 months | 0 | 159 | 232 | 6.6
5 months | Flurazepam stopped
| 4 days | 174 | 230 | 5.0 | Liver biopsy
| 7 days | 181 | 225 | 4.5
| 24 days | 79 | 183 | 1.7
6 months | 1 month | 59 | 142 | 1.0
6.5 months | 1.5 months | 47 | 104 | 0.6
Normal Values | | <49 | <90 | <1.2

#### Comment

Cholestatic hepatitis arose after 4 months of intermittent use of flurazepam. Other possible causes were tolbutamide, but the liver injury resolved despite it being continued. Mild self-limited cholestatic hepatitis is the typical pattern of benzodiazepine induced acute liver injury, but it is very rare and has not been associated with acute liver failure or chronic liver injury.

### Case 2. Cholestatic hepatitis due to flurazepam.(2)

A 44 year old Dutch woman visiting relatives in Canada, developed anorexia, nausea and abdominal discomfort. She had been taking flurazepam for insomnia intermittently for 6 months, but more frequently while visiting. After developing jaundice and pruritus, she was admitted for evaluation. She had no previous history of liver disease or risk factors for acquiring hepatitis and drank little alcohol. She took no other medications. She was jaundiced, but had no fever, rash or signs of chronic liver disease. Liver tests were elevated (Table). Ultrasound of the abdomen was unremarkable and HBsAg was negative. A liver biopsy showed intrahepatic cholestasis. Flurazepam was stopped and liver tests improved rapidly.

#### Key Points

Medication: | Flurazepam (30 mg orally nightly as needed)
Pattern: | Mixed (R=2.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 months to onset of symptoms
Recovery: | Complete recovery within one month after stopping
Other medications: | None

#### Laboratory Values

Time After Starting | Days After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
6 months | 0 | 106 | 209 | 8.2 | 8% Eosinophils
| 1 day | 122 | 203 | 8.3
| 3 days | 134 | 201 | 7.2 | Liver biopsy
| 6 days | 185 | 195 | 6.6
| 17 days | 108 | 121 | 2.0
| 4 weeks | 60 | 111 | 1.8
7 months | 5 weeks | 16 | 96 | 1.0
Normal Values | | <24 | <120 | <1.2

#### Comment

The benzodiazepines are widely used agents for therapy of anxiety, insomnia, tremor and some forms of seizures. They are extremely well tolerated and only rarely associated with significant liver injury. This case is typical of the rare instances of hepatotoxicity reported with benzodiazepines, marked by a self-limited cholestatic hepatitis arising after several months of use. Signs of hypersensitivity or autoimmunity are uncommon, although this patient had mild eosinophilia. Liver enzymes were only modestly elevated and the calculated R value suggested that the pattern of injury was “mixed.” However, the prominence of jaundice and pruritus along with the liver biopsy findings indicate that the injury was predominantly cholestatic.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flurazepam – Generic, Dalmane® (Trade name discontinued)

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=flurazepam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Flurazepam | 1172-18-5 | C21-H23-Cl-F-N3-O.2Cl-H

## CITED REFERENCES

1 Fang MH, Ginsberg AL, Dobbins WO. (1978). Cholestatic jaundice associated with flurazepam hydrochloride. Ann Intern Med.
2 Reynolds R, Lloyd DA, Slinger RP. (1981). Cholestatic jaundice induced by flurazepam hydrochloride. Can Med Assoc J.

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam or temazepam).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 517. (Review of benzodiazepine associated liver injury mentions that flurazepam is a rare cause of acute liver injury, most reported cases being cholestatic).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Fang MH, Ginsberg AL, Dobbins WO. (1978). Cholestatic jaundice associated with flurazepam hydrochloride. Ann Intern Med. (70 year old man developed fatigue and pruritis 2 months and jaundice 4 months after starting flurazepam [bilirubin 6.6 mg/dL, ALT 179 U/L, Alk P 232 U/L, no eosinophilia], improving only when drug withdrawn: Case 1).
Reynolds R, Lloyd DA, Slinger RP. (1981). Cholestatic jaundice induced by flurazepam hydrochloride. Can Med Assoc J. (44 year old woman taking flurazepam intermittently for 6 months developed abdominal pain [bilirubin 8.2 mg/dL, AST 106 U/L, Alk P 209 U/L], resolving rapidly upon stopping, biopsy showed intrahepatic cholestasis. Case 2).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 cases of hepatotoxicity reported from Denmark, 97 were due to psychotropic agents, but only two attributed to benzodiazepines).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is exceptionally rare).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine; “No child taking… benzodiazepines had raised liver enzyme levels,”).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to a benzodiazepine or sleeping pill).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to a benzodiazepine or sleeping pill).
(2012). Drugs for insomnia. Treat Guidel Med Lett. (Guidelines for therapy of insomnia mentions that benzodiazepines are controlled substances and when used for sleep may impair next day performance).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a benzodiazepine, despite the fact that millions of prescriptions are filled yearly).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to flurazepam or any other benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to flurazepam or any other benzodiazepine).
(2023). Drugs for chronic insomnia. Med Lett Drugs Ther. (Concise review of drugs for chronic insomnia mentions that tolerance and dependence can occur with use of benzodiazepines and their use should be discouraged, and that benzodiazepines are CNS suppressants and can impair next day performance including driving and cause complex behavior disorders, retrograde amnesia, dependence, tolerance, abuse and rebound insomnia; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Flurazepam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Flurazepam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Flurazepam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Flurazepam)